# Sarecycline

## OVERVIEW

### Introduction

Sarecycline is an oral, once daily, narrow spectrum tetracycline used to treat moderate-to-severe acne. Oral sarecycline use has rarely been linked to serum enzyme elevations during therapy and, although suspected of causing liver injury, it has yet to be linked to clinically apparent acute hepatic injury.

### Background

Sarecycline (sar" e sye' kleen) is an oral, narrow spectrum tetracycline antibiotic with potent activity against Cutibacterium acnes (formerly Propionibacterium acnes), a gram-positive organism that plays an important role in the inflammatory lesions of acne vulgaris. The tetracyclines act by inhibition of protein synthesis by binding to the 30S subunit of microbial ribosomes. Human cells are less susceptible to this inhibition. Tetracyclines have been available in the United States since the 1950s and used in therapy of several bacterial infections as well as acne. More modern forms of tetracycline include doxycycline, minocycline, and sarecycline, which have better absorption and tissue penetration. Sarecycline also has a more limited spectrum of antibacterial activity and was developed specifically for therapy of acne and to potentially avoid the complications of broad spectrum antibiotics such as Clostridium difficile colitis. Sarecycline was approved for use in moderate-to-severe acne in 2018 and is available in tablets of 60, 100, and 150 mg under the brand name Seysara. The recommended dose is based upon body weight and administered as a single tablet once daily (60 mg for 33-54 kg; 100 mg for 55-84 kg; and 150 mg for 85-136 kg). Typically, chronic long term and sometimes intermittent therapy is used for acne but the product label for sarecycline states that its efficacy beyond 12 weeks and safety beyond 12 months has not been established. Common side effects of sarecycline include gastrointestinal upset and nausea and less commonly poor appetite, diarrhea, glossitis, rash and hypersensitivity reactions. Tetracyclines can cause vertigo and tinnitus, skin photosensitivity reactions, intracranial hypertension (pseudotumor cerebri), and staining of developing teeth (in children or when taken by a pregnant mother) for which reason the tetracyclines should not be used in pregnant women or in children below the age of nine.

### Hepatotoxicity

In prelicensure clinical trials of sarecycline for facial acne, serum aminotransferase elevations were mild and no more frequent than with placebo or comparator arms. There were no instances of clinically apparent liver injury. Nevertheless, other tetracycline antibiotics, even when used in low doses, are well known causes of drug induced liver injury, particularly when given long term. Minocycline which is also used for acne is one of the most common causes of liver injury with jaundice. The injury typically arises after months or years of therapy and frequently presents as an autoimmune-like syndrome that can mimic lupus erythematosus, rheumatoid arthritis, or autoimmune hepatitis. While sarecycline has not been associated with a similar syndrome, it has not been widely used, and studies of its safety beyond 12 months has not been established.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which sarecycline might cause liver injury is unknown. It has minimal hepatic metabolism and has not been associated with significant CYP mediated drug-drug interactions. Minocycline associated liver injury has been association with carriage of the rare HLA allele B*35:02.

### Outcome and Management

Patients on long term sarecycline who develop serum aminotransferase elevations should be monitored more carefully and, if ALT or AST rise above 5 times the upper limit of normal or are accompanied by jaundice or symptoms (including arthralgias and rash), sarecycline should be discontinued. Whether there is cross sensitivity to hepatic injury among the various tetracyclines is not known, but switching to another tetracycline after drug induced liver injury from another should be done with caution and careful monitoring.

Drug Class: Antiinfective Agents, Tetracyclines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sarecycline – Seysara®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Sarecycline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Sarecycline | 1035979-44-2 | C24-H29-N3-O8

## ANNOTATED BIBLIOGRAPHY

References updated: 12 June 2026

Abbreviations used: ULN, upper limit of normal; iv, intravenous;

Zimmerman HJ. Tetracyclines. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 599-602. (Expert review of tetracycline and liver injury published in 1999; the tetracyclines cause two forms of drug induced liver injury, microvesicular fat and liver failure occurring after 4-10 days with high doses of parenteral tetracyclines and an idiosyncratic liver injury that occurs with the oral agents, doxycycline causing a cholestatic and minocycline a hepatocellular injury which may be associated with autoimmune features).
Moseley RH. Tetracyclines. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 468. (Expert review of tetracycline induced liver injury; mentions that the hepatotoxicity of intravenous tetracycline is of historic interest only as it is no longer given parenterally; both doxycycline and minocycline have been associated with idiosyncratic liver injury).
MacDougall C. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1049-65. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that pooled safety data indicated that serious adverse events were rare [<1%] and no more common with sarecycline [n=1820] than placebo [n=1113] treatment as were discontinuations for adverse events [1.3% vs 1.3%] and “there were no adverse effects with kidney or liver dysfunction” although 5 subjects discontinued sarecycline therapy because of liver enzyme elevations [one scored as “serious”], all of which were asymptomatic and resolved with stopping).
Moore A, Green LJ, Bruce S, Sadick N, Tschen E, Werschler P, Cook-Bolden FE, et al. Once-daily oral sarecycline 1.5 mg/kg/day is effective for moderate to severe acne vulgaris: results from two identically designed, phase 3, randomized, double-blind clinical trials. J Drugs Dermatol 2018; 17: 987-96. (Among 968 patients, ages 9 to 45 years, with facial acne treated with sarecycline or placebo for 12 weeks in 2 randomized controlled trials, inflammatory lesions improved more with sarecycline while adverse events included nausea [5%] and vomiting [2%] and more rarely dizziness and phototoxicity [<1%]; there were “no clinically meaningful differences … in clinical laboratory” measurements in either study). 30235387
Leyden JJ, Sniukiene V, Berk DR, Kaoukhov A. Efficacy and safety of sarecycline, a novel, once-daily, narrow spectrum antibiotic for the treatment of moderate to severe facial acne vulgaris: results of a phase 2, dose-ranging study. J Drugs Dermatol 2018; 17: 333-8. (Among 285 patients, ages 12 to 45 years, with severe facial acne vulgaris treated with 3 doses of sarecycline or placebo once daily for 12 weeks, inflammatory lesions were improved with higher doses of sarecycline vs placebo while adverse event rates were comparable and there were no serious adverse events; no mention of ALT elevations or hepatotoxicity). 29537451
Deeks ED. Sarecycline: first global approval. Drugs. 2019; 79: 325-9. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of sarecycline from clinical trials on which its FDA approval was based; mentions that adverse events were uncommon but included nausea, vomiting, abdominal pain, sunburn, vulvovaginal candidiasis and mycotic infections; no mention of ALT elevations or hepatotoxicity). 30659422
Pariser DM, Green LJ, Lain EL, Schmitz C, Chinigo AS, McNamee B, Berk DR. Safety and tolerability of sarecycline for the treatment of acne vulgaris: results from a phase III, multicenter, open-label study and a phase I phototoxicity study. J Clin Aesthet Dermatol. 2019;12:E53-E62. (Among 483 patients with moderate-to-severe acne treated with sarecycline in an open label extension study for up to 40 weeks, adverse events arose in 39% of patients but only 4 were considered serious none of which were considered liver-related; ALT elevations arose in 3 patients [0.6%], all of which were transient and less than 3 times ULN). 32038757
Del Rosso JQ, Draelos ZD, Effron C, Kircik LH. Oral sarecycline for treatment of papulopustular rosacea: results of a pilot study of effectiveness and safety. J Drugs Dermatol. 2021;20:426-431.. (Among 102 adults with moderate-to-severe papulopustular rosacea treated with sarecycline or a multivitamin control for 12 weeks, inflammatory lesions improved more with sarecycline and there were no serious adverse events; no mention of ALT elevations or hepatotoxicity). 33852248
Wei C, Liu Y, Jiang A, Wu B. A pharmacovigilance study of the association between tetracyclines and hepatotoxicity based on Food and Drug Administration adverse event reporting system data. Int J Clin Pharm. 2022;44:709-716. [] (Analysis of tetracyclines in the FDA’s Adverse Event Reporting System [FAERS] over a 16 year period identified 1435 cases of liver injury, the most with minocycline [n=547], doxycycline [545], tigecycline [288], and tetracycline [41] with few attributed to omadacycline [4], oxytetracycline [3], eravacycline [2], sarecycline [2], and demeclocycline [1]; no clinical details provided). 35364753
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 468 cases of idiosyncratic drug induced liver injury enrolled in a prospective Latin American database, 4 [0.9%] were attributed to minocycline, 1 [0.2%] each to doxycycline and tetracycline but none to eravacycline, omadacycline, sarecycline, or tigecycline). 38992407
Drugs for acne. Med Lett Drugs Ther. 2024;66(1695):17-20.. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for acne mentions that sarecycline is modestly effective and well tolerated; no mention of ALT elevations or hepatotoxicity). 38294764
Zhang J, He L, Chen X, Tu Y, Kostov B, Cabedo J, Baykal T, et al. Efficacy and safety of sarecycline in Chinese patients with moderate-to-severe acne vulgaris: randomized phase 3 clinical trial with open-label follow-up. Dermatol Ther (Heidelb). 2025;15:3285-3300. (Among 391 Chinese patients with moderate-to-severe acne treated with sarecycline or placebo for 12 weeks followed by a 36-weeks open-label extension study, inflammatory lesions improved more with sarecycline while adverse event rates were similar [48% vs 50%] including increases in ALT [3% vs 2%] and there were no instances of clinically apparent liver injury). 40877730

## OTHER REFERENCE LINKS

1. Recent References on Sarecycline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(sarecycline/AE+AND+tigecycline%5BNM%5D)+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver+OR+liver+diseases/CI)+AND+(%222008/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Sarecycline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=sarecycline)